# Piperacillin-Tazobactam

## OVERVIEW

### Introduction

Piperacillin is parenterally administered, extended-spectrum ureidopenicillin which, when combined with the beta-lactamase inhibitor tazobactam, is used to treat moderate-to-severe infectious due to susceptible organisms including lactamase producing penicillin-resistant bacteria. Piperacillin-tazobactam has been linked with idiosyncratic liver injury, including cases of DRESS and cholestatic liver injury that can be prolonged and even fatal.

### Background

Piperacillin-tazobactam is the combination of a fourth generation, extended-spectrum penicillin and a beta-lactamase inhibitor that is used for moderate-to-severe infections caused by susceptible agents, such as (but not limited to) Escherichia coli, many Bacteroides and Klebsiella species, Staphylococcus aureus, and Hemophilus influenzae. The combination of piperacillin with tazobactam provides broad activity against beta-lactamase producing penicillin-resistant bacterial species. This combination was approved for use in the United States in 1985 and is generally reserved for severe infections requiring parenteral therapy. Piperacillin-tazobactam is available in parenteral form for intravenous use in generic forms and under the trade name Zosyn. Recommended doses are 3 to 4.5 grams of piperacillin with 0.375 to 0.5 grams of tazobactam every 6 to 8 hours for 7 to 14 days. Common side effects include headache, dizziness, nausea, diarrhea, constipation, skin rash and hypersensitivity reactions. Rare but potentially severe adverse events include anaphylactic and hypersensitivity reactions, Stevens Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

In large clinical trials, ALT elevations were reported in 6% to 15% and bilirubin elevations in 3% to 5% of patients receiving piperacillin-tazobactam, with considerably lower rates in patients receiving comparator antibiotics (such as imipenim-cilastatin) and lower rates reported with piperacillin alone. These abnormalities were reported to resolve quickly with stopping therapy. Rare instances of idiosyncratic liver injury have been reported in persons receiving the piperacillin without tazobactam and a similar pattern of injury has been reported with the combination. The injury is typically cholestatic or mixed and arises 1 to 3 weeks after starting and often days or weeks after stopping the antibiotic. The liver injury is usually self-limited but severe cases of cholestatic hepatitis can lead to prolonged jaundice or persistence of minor alkaline phosphatase elevations for 6 to 12 months after clinical resolution. Immunoallergic features may be present but are generally mild.

In addition, the combination of piperacillin and tazobactam has been implicated in more than a dozen cases of drug rash with eosinophilia and systemic symptoms (DRESS) syndrome, usually arising after 2 to 3 weeks of long term therapy initially with rash and fever followed by liver or renal dysfunction or both. The liver injury is usually mixed or cholestatic but hepatocellular instances have also been reported. In many cases the liver injury is mild and overshadowed by the systemic symptoms and rash. Piperacillin-tazobactam has also been linked to instances of Stevens Johnson syndrome, although in most cases, other drugs known to be associated with the syndrome were being taken. These forms of hypersensitivity with liver involvement have not been reported with piperacillin alone. Because piperacillin-tazobactam is used for serious infections, patients are often taking multiple medications including other antibiotics such as vancomycin, azithromycin or ciprofloxacin, making the causality assessment challenging.

Likelihood score: B (likely rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury associated with piperacillin use is probably hypersensitivity or allergy. Cases of reoccurrence on reexposure have been reported. The role of tazobactam in the injury is uncertain, but it appears to be important in cases of DRESS syndrome.

### Outcome and Management

In the few cases of delayed cholestatic hepatitis that have been described with piperacillin with or without tazobactam, patients have recovered within a few weeks of stopping. Cases with DRESS syndrome tend to be more prolonged and are usually treated with corticosteroids for the manifestations of fever and rash. Whether corticosteroids also improve the liver and renal involvement is not clear, but they are generally continued for at least 6 to 8 weeks. Rechallenge is usually followed by recurrence of injury which can be more severe. Patients with piperacillin induced hepatitis should avoid reexposure and should take other penicillins and cephalosporins with caution.

Drug Class: Antiinfective Agents, Penicillins (Fourth Generation)

Other Drugs in the Class: Piperacillin, Ticarcillin, Ticarcillin-Clavulanate

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Piperacillin-Tazobactam – Generic, Zosyn®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=piperacillin+tazobactam)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Piperacillin-Tazobactam | 157044-21-8 | C23-H27-N5-O7-S. C10-H12-N4-O5-S.Na

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2020

Zimmerman HJ. Penicillins. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 595-6. (Expert review of penicillins and liver injury published in 1999; piperacillin and ticarcillin are listed as associated with elevations in aminotransferase levels, but without reports of clinically apparent liver injury except with ticarcillin-clavulanate).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics mentions that the extended-spectrum penicillins have rarely been associated with clinically apparent liver injury).
MacDougall C. Penicillins, cephalosporins, and other β-lactam antibiotics. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1023-38. (Textbook of pharmacology and therapeutics).
Winston DJ, Murphy W, Young LS, Hewitt WL. (1980). Piperacillin therapy for serious bacterial infections. Am J Med. (Piperacillin was given to 59 patients with severe infections; eosinophilia occurred in 6 and AST elevations in 2, none requiring discontinuation and all resolving with stopping).
Russo J, Russo ME. (1982). Comparative review of two new wide-spectrum penicillins: mezlocillin and piperacillin. Clin Pharm. (Review of two extended-spectrum penicillins, piperacillin is more active than mezlocillin against Pseudomonas, side effect profiles are similar including ALT elevations).
Gooding PG, Clark BJ, Sathe SS. (1982). Piperacillin: a review of clinical experience. J Antimicrob Chemother. (Review of registration trials including 493 courses of piperacillin, averaging 11 days: 90% cure, 4% hypersensitivity, 6% eosinophilia, 3% transient ALT elevations, 3% bilirubin elevations; one patient developed cholestatic hepatitis that recurred more severely with rechallenge).
Marier RL, Sanders CV, Faro S, et al. (1982). Piperacillin v Carbenicillin in the therapy for serious infections. Arch Intern Med. (Study of 165 hospitalized patients receiving either piperacillin or carbenicillin for serious infections; 95% vs 88% were cured, but liver test abnormalities occurred in 2% with piperacillin vs 22% with carbenicillin; 4% of patients were withdrawn, but none for jaundice).
Sharifi R, Lee M, Ojeda L. (1984). Comparative efficacy of piperacillin versus carbenicillin for complicated urinary tract infections. Urol Int. (Randomized clinical trial in complicated urinary tract infections for average of 7 days; mild ALT increases in 4% of 24 piperacillin recipients, but 35% [ALT 64-628 U/L, normal <27] of 17 carbenicillin recipients; no patient required early stopping).
Lang R, Lishner M, Ravid M. (1991). Adverse reactions to prolonged treatment with high doses of carbenicillin and ureidopenicillins. Rev Infect Dis. (Retrospective review of 63 patients who received carbenicillin or ureidopenicillins reported high rate of ALT elevations with Mezlocillin [20%] and one cause of jaundice, but none with carbenicillin or piperacillin).
Hargreaves JE, Herchline TE. (1992). Severe cholestatic jaundice caused by mezlocillin. Clin Infect Dis. (Case with onset of jaundice 15 days after starting mezlocillin, vancomycin and gentamicin [bilirubin 10 mg/dL, ALT 100 U/L, Alk P 960 U/L]; values worsened when switched to ampicillin, resolved once antibiotics were stopped).
Ryan J, Dudley FJ. (1992). Cholestasis with ticarcillin-potassium clavulanate (Timentin). Med J Aust. (75 year old man developed jaundice 31 days after stopping a 10 day course of ticarcillin-clavulanate [bilirubin 8.1 mg/dL, ALT 448 U/L, Alk P 1330 U/L]; died of progressive lymphoma soon thereafter; resembled liver injury associated with amoxicillin-clavulanate).
Kuye O, Teal J, DeVries VG, Morrow CA, Tally FP. (1993). Safety profile of piperacillin/tazobactam in phase I and III clinical studies. J Antimicrob Chemother. (Among 845 subjects in phase III studies, ALT elevations occurred in 12.2% and bilirubin elevations in 4.6% with iv piperacillin-tazobactam; higher than reported with comparators imipenem and aminoglycosides).
Wise R. (1993). The efficacy and safety of piperacillin/tazobactam in the therapy of bacteraemia. J Antimicrob Chemother. (Analysis of 142 patients treated in phase II-III studies found ALT elevations in 12% and bilirubin elevations in 9% of recipients of piperacillin-tazobactam, but no report of clinically apparent liver injury or withdrawal for liver abnormalities).
Arguedas A, Sifuentes-Osornio J, Loaiza C, Herrera M, Corrales JC, Mohs E. (1996). An open, multicenter clinical trial of piperacillin/tazobactam in the treatment of pediatric patients with intra-abdominal infections. J Chemother. (Analysis of 60 children with peritonitis receiving iv piperacillin-tazobactam for 1-15 days; 8% had ALT and 8% Alk P elevations, but all mild and resolving rapidly with stopping).
Quattropani C, Schneider M, Helbling A, Zimmermann A, Krähenbühl S. (2001). Cholangiopathy after short-term administration of piperacillin and imipenem/cilastatin. Liver. (20 year old man received one dose of piperacillin and 3 days of imipenem-cilastatin and developed symptomatic liver disease 2 weeks later[bilirubin 0.9 rising to 4.7 mg/dL, ALT 345- 669 U/L, Alk P 201-559 U/L], resolving within 2 months of stopping; unclear whether injury was due to piperacillin or imipenem: Case #1 in piperacillin record).
Dietze MA, Martin P, Schaaf-Lafontaine N. (2002). Rev Med Liege. (58 year old woman developed cholestatic hepatitis 12 days after starting 10 day course of piperacillin, but also 14 after 2 days of amoxicillin-clavulanate [peak bilirubin 15.0 mg/dL, ALT 624 U/L, Alk P 1730 U/L], resolving within 2 months).
Tan JS, Wishnow RM, Talan DA, Duncanson FP, Norden CW. (1993). Treatment of hospitalized patients with complicated skin and skin structure infections: double-blind, randomized, multicenter study of piperacillin-tazobactam versus ticarcillin-clavulanate. The Piperacillin/Tazobactam Skin and Skin Structure Study Group. Antimicrob Agents Chemother. (Among 251 patients treated with either of 2 fourth generation penicillins, overall rates of response and side effects were similar; no mention of ALT levels of hepatic adverse events).
Schoonover LL, Occhipinti DJ, Rodvold KA, Danziger LH. (1995). Piperacillin/tazobactam: a new beta-lactam/beta-lactamase inhibitor combination. Ann Pharmacother. (Review of pharmacology, efficacy and safety of piperacillin-tazobactam; the most common side effects are diarrhea [8%], nausea, headache, pruritus and rash [1%]; laboratory abnormalities occur in <1% of patients, but can include "transient increases in liver function test results"; no other mention of hepatotoxicity).
Dietze MA, Martin P, Schaaf-Lafontaine N. (2002). Rev Med Liege. (58 year old woman developed cholestatic hepatitis 12 days after starting 10 day course of piperacillin, but also 14 days after finishing a 2 day course of amoxicillin-clavulanate [peak bilirubin 15.0 mg/dL, ALT 624 U/L, Alk P 1730 U/L], resolving within 2 months).
Yellin AE, Johnson J, Higareda I, Congeni BL, Arrieta AC, Fernsler D, West J, et al. (2007). Ertapenem or ticarcillin/clavulanate for the treatment of intra-abdominal infections or acute pelvic infections in pediatric patients. Am J Surg. (Among 105 children in a controlled trial, ALT elevations occurred in 3% on ertapenem vs 4% on ticarcillin-clavulanate; no details given).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, two cases were attributed to amoxicillin, but none were attributed to ticarcillin or piperacillin).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. (2010). Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to an extended spectrum penicillin).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, but ticarcillin and piperacillin were not listed in the top 41 causes).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to an extended spectrum penicillin).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 due to amoxicillin-clavulanate, 1 to dicloxacillin [2nd generation] and 1 to phenoxymethylpenicillin [1st generation], the latter two cases being anicteric; none were attributed to a 4th generation penicillin).
Sistanizad M, Peterson GM. (2013). Drug-induced liver injury in the Australian setting. J Clin Pharm Ther. (Among 17 persons with suspected drug induced liver injury seen over at 12 month period at a referral hospital in Tasmania, 11 were attributed to antibiotics including 4 to flucloxacillin, 2 amoxicillin with clavulanate, 2 amoxicillin, and 1 each to rifampin, moxifloxacin and ciprofloxacin; none to 4th generation penicillins).
Devarbhavi H, Andrade RJ. (2014). Drug-induced liver injury due to antimicrobials, central nervous system agents, and nonsteroidal anti-inflammatory drugs. Semin Liver Dis. (Review of drug induced liver injury from various classes of agents, mentions that amoxicillin-clavulanate is the leading cause of drug induced liver injury, marked by a latency of several days to weeks, often after stopping the antibiotic, the injury varying from cholestatic to hepatocellular and the mortality rate being as high as 7%; no discussion of the 4th generation penicillins).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury from Latin American countries published between 1996 and 2012 identified 176 cases, of which 37 [19%] were attributed to antimicrobials, including one to benzathine penicillin and 3 to amoxicillin-clavulanate, but none to 4th generation penicillins such as piperacillin or ticarcillin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics of which 106 [12%] were due to penicillins including one to a 1st, three to a 2nd [all due to oxacillin], 97 to a 3rd [91 to amoxicillin-clavulanate, and 6 to amoxicillin alone] and five to a 4th generation penicillin [all 5 to piperacillin-tazobactam]).
Guéant JL, Romano A, Cornejo-Garcia JA, Oussalah A, Chery C, Blanca-López N, Guéant-Rodriguez RM, et al. (2015). HLA-DRA variants predict penicillin allergy in genome-wide fine-mapping genotyping. J Allergy Clin Immunol. (In a genome wide association study of 387 patients with immediate allergic reactions to beta-lactam antibiotics, several class 2 HLA associations [HLA-DRA regions] were found for penicillin responses).
Björnsson ES. (2016). Hepatotoxicity by drugs: the most common implicated agents. Int J Mol Sci. (Review of the most common causes of drug induced liver injury based upon categorization from LiverTox, amoxicillin-clavulanate but not other forms of penicillin were in the top category of causes of liver injury [likelihood scores of A, with more than 100 cases published in the literature]).
Faulkner L, Gibson A, Sullivan A, Tailor A, Usui T, Alfirevic A, Pirmohamed M, et al. (2016). Detection of primary T cell responses to drugs and chemicals in HLA-typed volunteers: implications for the prediction of drug immunogenicity. Toxicol Sci. (Demonstration of T cell priming to drugs linked with specific class I HLA-alleles).
Nicoletti P, Aithal GP, Björnsson ES, Andrade RJ, Sawle A, Arrese M, Barnhart HX, et al., International Drug-Induced Liver Injury Consortium, Drug-Induced Liver Injury Network Investigators, and International Serious Adverse Events Consortium. (2017). Association of liver injury from specific drugs, or groups of drugs, with polymorphisms in HLA and other genes in a genome-wide association study. Gastroenterology. (A genome wide association study done on 862 Caucasian patients with drug induced liver injury demonstrated a strong link with HLA-A*33:01 in those with cholestatic liver injury, particularly in cases attributed to terbinafine, fenofibrate and ticlopidine).
Cabañas R, Calderon O, Ramirez E, Fiandor A, Prior N, Caballero T, Herránz P, et al. (2014). Piperacillin-induced DRESS: distinguishing features observed in a clinical and allergy study of 8 patients. J Investig Allergol Clin Immunol. (Eight patients with DRESS syndrome attributed to piperacillin-tazobactam were identified at a single Spanish referral center in Madrid between 2006 and 2012; 3 women, 5 men, ages 39 to 83 years, all with rash and eosinophilia, 6 with liver involvement [mixed or cholestatic injury] but none with jaundice, 3 with renal involvement, all survived).
Blumenthal KG, Youngster I, Rabideau DJ, Parker RA, Manning KS, Walensky RP, Nelson SB. (2015). Peripheral blood eosinophilia and hypersensitivity reactions among patients receiving outpatient parenteral antibiotics. J Allergy Clin Immunol. (Among 824 patients who underwent outpatient parenteral antibiotic therapy for at least 2 weeks, 210 [25%] developed eosinophilia including 58 of 207 [28%] who received “penicillins” of whom 3 developed signs of “possible” DRESS syndrome; specific penicillins accounting for the cases were not provided).
Tailor A, Faulkner L, Naisbitt DJ, Park BK. (2015). The chemical, genetic and immunological basis of idiosyncratic drug-induced liver injury. Hum Exp Toxicol. (Review of mechanisms of idiosyncratic drug induced liver injury focusing upon chemically reactive drug metabolites and genetic associations, particularly those with HLA alleles that implicate the adaptive immune response).
Kraleti S, Khatri N, Jarrett D. (2016). Piperacillin-tazobactam induced interstitial nephritis, hepatitis and serum sickness-Like Illness. J Ark Med Soc. (30 year old woman developed fever and rash during intravenous therapy with vancomycin and piperacillin-tazobactam with accompanying liver and kidney disfunction and leukocytosis [bilirubin 2.3 mg/dL, ALT 180 U/L, Alk P 708 U/L, INR 2.5, creatinine 5.4], responding rapidly to stopping therapy and treatment with corticosteroids).
Patel J, Walayat S, Kalva N, Palmer-Hill S, Dhillon S. (2016). Bile cast nephropathy: a case report and review of the literature. World J Gastroenterol. (54 year old man developed jaundice 2 weeks after starting intravenous piperacillin-tazobactam for osteomyelitis with progressive jaundice and renal dysfunction [bilirubin 19.3 rising to 29.0 mg/dL, ALT 129 U/L, Alk P 851 U/L, INR 1.4, creatinine 2.1 rising to 5.5 mg/dL], treated with dialysis and ursodiol but after six months of progressive disease underwent successful, combined renal and liver transplant).
Cirulli ET, Nicoletti P, Abramson K, Andrade RJ, Björnsson ES, Chalasani N, Fontana RJ, et al., Drug-Induced Liver Injury Network (DILIN) investigators. (2019). International DILI consortium (iDILIC). A missense variant in PTPN22 is a risk factor for drug-induced liver injury. Gastroenterology. (Genome wide association studies on 2048 patients with drug induced liver injury and 12,439 controls identified a variant in PTPN22 which was highly associated with liver injury, allele frequency being 0.12 among cases and 0.08 among controls with highest association in Northern Europeans and in cases of amoxicillin-clavulanate, PTPN22 being a cellular kinase involved in modulation of immune reactions).

## OTHER REFERENCE LINKS

1 Recent References on Piperacillin-Tazobactam: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=((piperacillin/AE+AND+tazobactam%5BNM%5D)+OR+piperacillin/AE)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D)
2 Trials on Piperacillin-Tazobactam: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=piperacillin+tazobactam)